# Risankizumab

## OVERVIEW

### Introduction

Risankizumab is a humanized monoclonal antibody to IL-23 which is used to treat moderate-to-severe plaque psoriasis. Risankizumab is generally well tolerated and is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent liver injury.

### Background

Risankizumab (ris” an kiz’ ue mab) is a humanized monoclonal IgG1 antibody directed against the p19 subunit of IL-23, which results in inhibition of IL-23 signaling and decrease in synthesis of proinflammatory cytokines such as IL-17. Risankizumab has been evaluated as therapy of several immune and inflammatory conditions, most extensively in plaque psoriasis. In several large, preregistration randomized controlled trials, 48 weeks of risankizumab therapy resulted in a significant improvement in psoriatic skin lesions in more than 70% of patients. Clinical responses were generally maintained with long term therapy. Risankizumab was approved in the United States in 2019 as therapy for moderate-to-severe plaque psoriasis in adult candidates for systemic therapy. It is also being evaluated in patients with psoriatic arthritis, inflammatory bowel disease and atopic dermatitis. Risankizumab is available in single dose pre-filled syringes of 75 mg in 0.83 mL under the brand name Skyrizi. The recommended dose is 150 mg (two syringes) administered subcutaneously at weeks 0 and 4 followed by every 12 weeks thereafter. Common side effects include mild local injection reactions, nasopharyngitis, fatigue, headache, arthralgia and skin rashes. Uncommon, potentially severe adverse reactions include severe infections, reactivation of tuberculosis and skin cancer.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise in up to 10% of patients treated with risankizumab, but the abnormalities are generally transient and asymptomatic, rarely necessitating drug discontinuation. In large, preregistration trials there were no instances clinically apparent liver injury or severe hepatic adverse events attributed to risankizumab. Since its approval and more general use, there have been no reports of clinically significant liver injury attributed to risankizumab.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to risankizumab are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of IL23 signaling would trigger liver injury or autoimmune liver conditions.

Drug Class: Monoclonal Antibodies, Psoriasis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Risankizumab – Skyrizi®

DRUG CLASS

Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Risankizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Risankizumab | 1612838-76-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 09 June 2021

Sewell MJ, Burkhart CN, Morrell DS. Dermatology pharmacology. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761105Orig1s000MultidisciplineR.pdf (Multidisciplinary FDA review of risankizumab in support of its approval for use in moderate-to-severe plaque psoriasis in the US with discussion of safety, which mentions that there were no serious hepatic adverse events attributed to risankizumab and that evaluation of changes in “…clinical chemistry values did not identify any significant safety concerns”).
Papp KA, Blauvelt A, Bukhalo M, Gooderham M, Krueger JG, Lacour JP, Menter A, et al. (2017). Risankizumab versus ustekinumab for moderate-to-severe plaque psoriasis. N Engl J Med. (Among 166 patients with moderate-to-severe plaque psoriasis treated with risankizumab or ustekinumab for 16 weeks, clinical response rates were higher with risankizumab [77% vs 40%], while total adverse event rates were similar 81% vs 80% and there were no serious adverse events attributed to either medication).
Gordon KB, Strober B, Lebwohl M, Augustin M, Blauvelt A, Poulin Y, Papp KA, et al. (2018). Efficacy and safety of risankizumab in moderate-to-severe plaque psoriasis (UltIMMa-1 and UltIMMa-2): results from two double-blind, randomised, placebo-controlled and ustekinumab-controlled phase 3 trials. Lancet. (Among 997 patients with moderate-to-severe plaque psoriasis treated in two controlled trials, clinical response rates were highest with risankizumab [75%], than with ustekinumab [42-48%] or placebo [2-5%], while adverse event rates were similar in all three groups and there were no episodes of reactivation of tuberculosis, severe hypersensitivity reactions, cancer [other than non-melanoma skin cancer] or major cardiovascular events attributed to therapy; no mention of ALT elevations or hepatotoxicity).
(2019). Risankizumab (Skyrizi) for psoriasis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of risankizumab shortly after its approval for use in the US for plaque psoriasis, mentions side effects of nasopharyngitis, headache and arthralgia; no mention of ALT elevations or hepatotoxicity).
(2019). Drugs for psoriasis. Med Lett Drugs Ther. (Concise review of drugs approved for therapy of psoriasis in the US including calcipotriene, tazarotene, phototherapy, methotrexate, cyclosporine, acitretin, apremistat, tumor necrosis factor inhibitors, IL-17A antagonists and IL-23 inhibitors).
McKeage K, Duggan S. (2019). Risankizumab: first global approval. Drugs. (Review of the chemical structure, mechanism of action, pharmacology, clinical efficacy and safety of risankizumab mentions that common adverse events include injection site reactions, headache, arthralgia and upper respiratory infection symptoms, and uncommon potential severe adverse reactions include infections, reactivation of tuberculosis and cancer).
Reich K, Gooderham M, Thaçi D, Crowley JJ, Ryan C, Krueger JG, Tsai TF, et al. (2019). Risankizumab compared with adalimumab in patients with moderate-to-severe plaque psoriasis (IMMvent): a randomised, double-blind, active-comparator-controlled phase 3 trial. Lancet. (Among 605 patients with moderate-to-severe plaque psoriasis treated with Risankizumab vs adalimumab for 16 weeks, clinical response rates were higher with risankizumab [84% vs 60%] while adverse event rates were similar [56% vs 57%, severe in 3% vs 3%, and hepatic in 2% vs 1%], one person developing a severe hepatitis that was attributed to isoniazid therapy of latent tuberculosis).
Blauvelt A, Leonardi CL, Gooderham M, Papp KA, Philipp S, Wu JJ, Igarashi A, et al. (2020). Efficacy and safety of continuous risankizumab therapy vs treatment withdrawal in patients with moderate to severe plaque psoriasis: a phase 3 randomized clinical trial. JAMA Dermatol. (Among 507 patients with moderate-to-severe plaque psoriasis treated with risankizumab vs placebo for 16 weeks, clinical response rates were higher with risankizumab while total and severe adverse event rates were similar [46% vs 49% and 2% vs 4%], although hepatic adverse events occurred in 7% vs 2% including ALT elevations in 1.8% vs 0.4%).
Warren RB, Blauvelt A, Poulin Y, Beeck S, Kelly M, Wu T, Geng Z, et al. (2021). Efficacy and safety of risankizumab vs. secukinumab in patients with moderate-to-severe plaque psoriasis (IMMerge): results from a phase III, randomized, open-label, efficacy-assessor-blinded clinical trial. Br J Dermatol. (Among 327 patients with moderate-to-severe plaque psoriasis treated with risankizumab or secukinumab for one year, clinical response rates were higher with risankizumab [74% vs 66% at week 16 and 87% vs 57% at week 52], while total and severe adverse event rates were similar [71% vs 71% and 5.5% vs 4%]; no mention of ALT elevations or hepatotoxicity).
Papp KA, de Vente S, Zeng J, Flack M, Padilla B, Tyring SK. (2021). Long-term safety and efficacy of risankizumab in patients with moderate-to-severe chronic plaque psoriasis: results from a phase 2 open-label extension trial. Dermatol Ther (Heidelb). (Among 110 patients with moderate-to-severe plaque psoriasis enrolled in an one year open label extension study of risankizumab after a randomized controlled trial, 74% achieved a clinical response by week 48 and adverse events arose in 77%, which were considered “hepatic” in 4.5%).
Ferrante M, Feagan BG, Panés J, Baert F, Louis E, Dewit O, Kaser A, et al. Long-term safety and efficacy of risankizumab treatment in patients with Crohn's disease: results from the phase 2 open-label extension study. J Crohns Colitis 2021 Jun 2: jjab093. Epub ahead of print. (Among 65 patients with Crohn’s disease treated with risankizumab [180mg every 8 weeks] in an open label extension study for a median of 33 months, the adverse event rate was 25 per 100 patient-years including hepatic events [mostly ALT or AST elevations above 5 times ULN] of 10 per 100 patient years).

## OTHER REFERENCE LINKS

1 Recent References on Risankizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Risankizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Risankizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Risankizumab)